# Tetracycline

## OVERVIEW

### Introduction

Tetracycline is an oral, broad-spectrum antibiotic used to treat mild-to-moderate infections due to susceptible microbial organisms. High doses of several forms of tetracycline given intravenously have been associated with acute fatty liver that can be severe and result in liver failure and death. Oral tetracycline use has been rarely and not very convincingly linked to acute hepatic injury.

### Background

Tetracycline is an oral, broad-spectrum antibiotic and a derivative of Streptomyces species. Tetracycline acts by inhibition of protein synthesis by binding to the 30S ribosomal subunit. Human cells are less susceptible to this inhibition. Tetracycline was first approved for use in the United States in the early 1950s and was one of several oral tetracyclines used at that time (oxytetracycline, chlortetracycline), many of which are no longer available or are used in veterinary medicine only. More modern forms of tetracycline include doxycycline and minocycline which are much more commonly used and have similar indications. Currently, tetracycline is most frequently used for upper respiratory and skin and soft tissue infection and more than a million prescriptions are filled yearly. Chronic therapy with tetracycline is effective in ameliorating acne, but because of their better absorption and tissue penetration, minocycline and doxycycline have largely replaced tetracycline for this indication. Tetracycline is also active against infections with several rickettsial, spirochetal, chlamydial and mycoplasmas infections and are often used for therapy of nonspecific urethritis and several Rickettsia diseases, such as Rocky Mountain spotted fever and Lyme disease. Tetracycline is available in multiple generic forms as capsules or tablets of 250 and 500 mg and generally recommended in doses of 250 to 500 mg three to four times daily for 7 to 30 days. Chronic therapy is typical for therapy of acne. Pediatric formulations as oral suspension are also available. Parenteral tetracycline is no longer used. Common side effects of oral tetracycline include gastrointestinal upset, nausea, poor appetite, diarrhea, glossitis, rash and hypersensitivity reactions. Tetracycline can cause staining of developing teeth (in children or when taken by a pregnant mother) for which reason it should not be used during pregnancy or in children less than 9 years of age.

### Hepatotoxicity

High doses of intravenous tetracycline can induce fatty liver disease and may result in severe hepatic dysfunction, acute liver failure and death. This syndrome is more common among pregnant women, largely during the last trimester or early postpartum period. However, instances of acute fatty liver attributed to intravenous tetracycline have been reported in nonpregnant women and in men and even in children. The injury is characterized by onset of weakness, fever, fatigue, nausea and abdominal pain after 3 to 10 days of therapy. Laboratory tests show minimal-to-moderate elevations in serum aminotransferase and alkaline phosphatase levels with mild jaundice, but presence of hyperammonemia and coagulopathy. Pancreatitis, renal dysfunction and lactic acidosis are also common, although not always specifically sought. The syndrome may be reversible if tetracycline is stopped promptly, but it is usually recognized late and can progress to multiorgan failure and death despite stopping the agent. This syndrome also occurs with high doses of intravenous tigecycline and possibly with doxycycline, but quite rarely. This syndrome is rarely seen currently as tetracycline is no longer available in parenteral form and the use of intravenous tetracyclines has been superseded by availability of safer, better tolerated and more effective broad spectrum antibiotics.

Oral tetracycline has been associated with rare instances of acute liver injury, but the association with tetracycline use as opposed to other agents being taken has not always been very well shown. Despite frequency of its use, oral tetracycline remains a very rare cause of liver injury. In contrast, cases of doxycycline and minocycline induced liver disease are well described. Rare instances of acute fatty liver have been attributed to oral tetracycline, particularly when given to pregnant women in high doses. Currently, tetracycline is considered contraindicated in pregnant women, particularly during the last trimester.

Likelihood score: A[HD] (well known cause of clinically apparent liver injury when given in high doses intravenously).

### Mechanism of Injury

The hepatic injury from intravenous forms of tetracycline was likely due to mitochondrial injury due to inhibition of mitochondrial protein synthesis, although another possibility is that tetracycline interferes with fat metabolism in hepatocytes. The injury is less idiosyncratic than direct, varying in frequency and severity based upon pharmacokinetics and host metabolic factors (age, pregnancy, drug accumulation, and other factors affecting mitochondrial function). The rare idiosyncratic forms of liver injury from tetracycline are of unknown cause, but are likely to be immunoallergic.

### Outcome and Management

Acute fatty liver due to tetracycline has a high fatality rate and is best managed with intensive care and attention to multiorgan support. Lactic acidosis should be treated with intravenous glucose (20% infusions) and bicarbonate. Idiosyncratic acute liver injury from tetracycline is rare and usually resolves rapidly once the agent is withdrawn. An instance of chronic cholestasis with vanishing bile duct syndrome has been reported, although the patient had received several medications that also might have accounted for the hepatic injury.

Drug Class: Antiinfective Agents, Tetracyclines

## CASE REPORT

### Case 1. Liver failure from intravenous tetracycline.(1)

A 72 year old man treated for cystitis and diverticulitis with 10 days of iv tetracycline developed lactic acidosis and multiorgan failure. The patient had no previous history of liver disease or risk factors for hepatitis. When initially admitted to the hospital, he had fever, abdominal pain, leukocytosis and an abnormal urinalysis, but liver tests were normal (Table). He was treated with hydration and iv tetracycline in doses of 3 grams daily. His fever improved slowly, but by day 4, liver tests were mildly abnormal and they had worsened by day 8. Colistin was added on day 6, and chloramphenicol was substituted for tetracycline on day 10. The following day, he developed progressive restlessness, stupor and respiratory failure. He had renal failure and severe acidosis and he died within hours of attempting resuscitation and dialysis. Autopsy showed an enlarged fatty liver with minimal inflammation and no obvious hepatocellular necrosis. Fat was also identified in renal tubular cells. There was marked ascites and hemorrhagic pancreatitis.

#### Key Points

Medication: | Tetracycline (3 g iv daily for 10 days)
Pattern: | Hepatocellular
Severity: | 5+ (death from hepatic failure and lactic acidosis)
Latency: | 4 days
Recovery: | Fatal
Other medications: | Colistin and chloramphenicol (after onset of liver injury)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P* (KAU/L) | Bilirubin (mg/dL) | Other
0 | Pre | 32 | 8 | 0.3 | Started iv tetracycline
4 days | | 190 | 10 | 2.4 | BUN 39 mg/dL
8 days | | 530 | 11.5 | 2.2 | Colistin added im q 12 hr
10 days | 0 | Tetracycline stopped; chloramphenicol started.
11 days | 1 day | 1550 | 15 | 6.8 | BUN 105; CO2 11 mEq/L
Increasing stupor and respiratory failure, hemodialysis and resuscitative measures failed.
Normal Values | | <40 | <13 | <1.2

* King Armstrong units

#### Comment

Acute fatty liver caused by tetracycline was initially thought to occur only in pregnant women during the last trimester, but was subsequently reported to occur at other times during pregnancy, after delivery, in nonpregnant women, in men and even in children. The syndrome typically occurs after 3 to 10 days of relatively high doses of im or iv tetracycline. The case above is typical in demonstrating that the precipitous onset of symptoms is a late phenomenon and has a grim prognosis; symptoms are preceded by several days of worsening liver injury, although laboratory tests may be only mildly or moderately abnormal. Acute fatty liver is accompanied by minimal hepatic inflammation and liver cell necrosis and is a syndrome of marked mitochondrial failure, early appearance of hepatic synthetic dysfunction and lack of ATP to drive normal metabolism. The injury is not confined to the liver, and renal failure and pancreatitis are common. As in this case, the immediate cause of death is typically multiorgan failure due to lactic acidosis or pancreatitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tetracycline – Generic, Sumycin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tetracyclines)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Tetracycline Hydrochloride | 64-75-5 | C22-H24-N2-O8.Cl-H

## CITED REFERENCES

1 Robinson MJ, Rywlin AM. Tetracycline-associated fatty liver in the male. Report of an autopsied case. Am J Dig Dis 1970; 15: 857-62. 5459744

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal; iv, intravenous; ANA, antinuclear antibody.

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
Lepper MH, Wolfe CK, Zimmerman HJ, Cladwell ER Jr, Spies HW, Dowling HF. Effect of large doses of aureomycin on human liver. Arch Intern Med 1951; 88: 271-83. (Description of hepatotoxicity among 101 patients treated with aureomycin over a 30 month period; 7 had clinically apparent liver injury, all received high doses [>3 g] intravenously with onset of vomiting and mental changes followed by jaundice after 3-12 days; autopsy showed fatty liver). 14856456
Rutenburg AM, Pinkes S. The hepatotoxicity of intravenous aureomycin. N Engl J Med 1952; 247: 797-800. (Serum bilirubin rose in some patients given iv aureomycin and some became “jaundiced”, but may have been partially an artifact of colorimetric method of bilirubin detection). 13002619
Domz CA, McNamara DH, Holzapfel HF. Tetracycline provocation in lupus erythematosus. Ann Intern Med 1959; 50: 1217-26. (3 cases of apparent worsening of systemic lupus erythematosus after course of oxytetracycline for incurrent infection; no hepatic component mentioned). 13650436
Ticktin HE, Zimmerman HJ. Hepatic dysfunction and jaundice in patients receiving triacetyloleandomycin. N Engl J Med 1962; 267: 964-8. Not in PubMed (50 “mental defectives or juvenile delinquents” were given triacetyloleandomycin [1 g orally per day] for 3-4 weeks with close monitoring, BSP retention increased in 54% by week 2, AST in 34%, ALT in 8%, 12% had symptoms, 4% jaundice; liver biopsy showed mixed cholestatic-hepatic picture in 2; rechallenge led to increases in AST and bilirubin in 2 within 1-2 days; all ultimately resolved).
Schultz JC, Adamson JS Jr, Workman WW, Norman TD. Fatal liver disease after intravenous administration of tetracycline in high dosage. N Engl J Med 1963; 269: 999-1004. (Initial dramatic report of acute fatty liver due to iv tetracycline; a rapidly fatal multisystem disease appeared in 6 pregnant women in their last trimester or early postpartum period after 3 to 5 days of relatively high doses of iv tetracycline; all developed jaundice [bilirubin 4.9-12.5 mg/dL] with mild AST [72-170 U/L] and Alk P [9-17 King Armstrong U/L] elevations, prolongation of protime, acidosis and renal dysfunction. Autopsy showed foamy hepatocytes, fat by oil red O stain and minimal hepatocyte necrosis). 14059734
Tetracycline hepatotoxicity. Br Med J 1964; 2: 1545-6. (Editorial on the recently described syndrome of acute fatty liver in pregnant women receiving iv tetracycline). 14211749
Dowling HF, Lepper MH. Hepatic reactions to tetracycline. JAMA 1964; 188: 307-9. (Review of literature on acute fatty liver due to tetracycline and recommendations on its use: avoiding doses >2 g/day and cautious use in women in last trimester of pregnancy). 14114004
Horwitz ST, Marymont JH Jr. Fatal liver disease during pregnancy associated with tetracycline therapy. Report of a case. Obstet Gynecol 1964; 23: 826-9. (After complicated Caesarian and emergency hysterectomy with shock and bleeding, 41 year old woman received tetracycline given iv for 4 days, then orally to day 8; on day 10 she developed fever, acidosis and ileus, dying on day 16 with multiorgan failure and jaundice; autopsy showed fatty liver). 14168241
Norman TD, Schultz JC, Hoke RD. Fatal liver disease following the administration of tetracycline. South Med J 1964; 57: 1038-42. (Further analysis of 6 cases of acute fatty liver after tetracycline in pregnant women with histological changes). 14179316
Whalley PJ, Adams RH, Combes B. Tetracycline toxicity in pregnancy. Liver and pancreatic dysfunction. JAMA 1964; 189: 357-62. (Five cases of acute fatty liver with azotemia and pancreatitis after 4-17 days of iv or oral therapy 1-2 g/day: bilirubin 1.2-18.8 mg/dL; AST 34-780 U/L; Alk P 8.6-22 BU/L; 1 case fatal. The anicteric case had pancreatitis and was attributed to oral drug, but had fat on liver biopsy). 14160508
Brewer T. Tetracycline hepatotoxicity. Br Med J 1965; 1: 995. (Letter questioning role of tetracycline in acute fatty liver). 14260641
Finn WF, Horwitz ST. Maternal death due to fatty metamorphosis of liver following tetracycline therapy. N Y State J Med 1965; 65: 662-7. (After Caesarian section, followed by hysterectomy and pneumonia, 41 year old woman received iv tetracycline for 4 days, followed by oral and then iv drug again, developing shock and jaundice; autopsy showed fatty liver without necrosis). 14251580
Ichida F, Watanabe K, Ishiwara S, Inoue K, Tanabe Y. [A case of cholestatic jaundice due to tetracycline-triacetyloleandomycin] Nippon Naika Gakkai Zasshi 1965; 54:142-7. Japanese. PMID: 5294320
Kunelis CT, Peters JL, Edmondson HA. Fatty liver of pregnancy and its relationship to tetracycline therapy. Am J Med 1965; 38: 359-77. (Classical clinical and histologic description of syndrome in 12 pregnant women, ages 19-31, given tetracycline for 3 to 12 days [total dose 1.5 to 14 g] after 16-39 weeks of pregnancy [bilirubin 12-19.8 mg/dL, ALT 24-210 U/L, AST 36-760 U/L, lactic acid high in 3/3 patients], 67% fatal, often accompanied by multiorgan failure, pancreatitis and shock). 14266828
Tapp E, Carroll R. Tetracycline accumulation in toxic liver damage. J Pathol Bacteriol 1965; 89: 715-21. (Animal studies showing accumulation of tetracycline in damaged hepatocytes, particularly with high levels of calcium). 14320315
Winterling AN, Goldman RL. Hepatic and renal lesions in a case of tetracycline toxicity during long-term estrogen therapy after orchiectomy. Calif Med 1965; 102: 314-6. (66 year old man post-orchiectomy for prostate cancer developed sudden onset of fever, lactic acidosis and mild jaundice [bilirubin 2.9 mg/dL] after 8 days of iv tetracycline [17 g], subsequently died after emergency laparotomy; autopsy showed fatty liver). 14291456
Wruble LD, Ladman AJ, Britt LG, Cummins AJ. Hepatotoxicity produced by tetracycline overdosage. JAMA 1965; 192: 6-8. (56 year old woman with cecal volvulus developed jaundice [bilirubin 7.8 mg/dL, AST 98 U/L, Alk P normal] 2 days after receiving 8 g of tetracycline, subsequently progressing to liver failure and death; autopsy showed fatty liver). 14262279
Wruble LD, Cummins AJ. Tetracycline and fatty liver. Am J Dig Dis 1965; 10: 742-4. (Editorial on tetracycline induced acute fatty liver with discussion of mechanisms focusing on mitochondrial injury). 14316764
Tetracyclines and the liver in pregnancy. Lancet 1966; 1: 357-8. (Editorial on the history of acute fatty liver of pregnancy, first described by Sheehan in 1940 and later linked to high dose iv tetracycline in pregnancy, but also in nonpregnant women and in men). 4159865
Allen ES, Brown WE. Hepatic toxicity of tetracycline in pregnancy. Am J Obstet Gynecol 1966; 95: 12-8. (Prospective study done in 18 pregnant women who underwent liver biopsy and then were given 1-6 g of tetracycline [n=9] or oxytetracycline [n=9] intravenously for 3 days, at which time liver biopsy was repeated; increased AST [16 to 134 U/L] in 1, increase in fat in liver in most, but only detectable by oil red O stain, not by usual stains). 5934994
Davis JS, Kaufman RH. Tetracycline toxicity. A clinicopathologic study with special reference to liver damage and its relationship to pregnancy. Am J Obstet Gynecol 1966; 95: 523-9. (6 cases of acute fatty liver, 1 man and 5 women [4 pregnant] given intravenous tetracycline for 9-10 days [3-6 g] [bilirubin 3-12.5 mg/dL, ALT 34-310 U/L], all acidotic and all died, autopsy showing fatty liver). 5939019
Schiffer MA. Fatty liver associated with administration of tetracycline in pregnant and nonpregnant women. Am J Obstet Gynecol 1966; 96: 326-32. (Six cases of acute fatty liver from tetracycline, 2 in pregnancy at 34- and 40 weeks; 4 in nonpregnant women, but clinical course not described). 5919490
Aach R, Kissane J eds. Clinicopathologic conference. A seventeen-year-old girl with fatty liver of pregnancy following tetracycline therapy. Am J Med 1967; 43: 274-83. (Clinicopathologic conference describing 17 year old pregnant woman who developed suspected pyelonephritis, was treated with im and oral tetracycline and 8 days later developed multiorgan failure, lactic acidosis and died despite induced delivery of a stillborn child). 6034958
Lewis M, Schenker S, Combes B. Studies on the pathogenesis of tetracycline-induced fatty liver. Am J Dig Dis 1967; 12: 429-38. (Rats given high doses of iv tetracycline develop fat in liver with higher concentrations in pregnant rats, despite similar serum and hepatic concentrations of drug). 6026422
Peters RL, Edmondson HA, Mikkelsen WP, Tatter D. Tetracycline-induced fatty liver in nonpregnant patients. A report of six cases. Am J Surg 1967; 113: 622-32. (Classical description of clinical and histologic features of tetracycline induced acute fatty liver in nonpregnant patients; 6 nonpregnant women, ages 18-62, given iv tetracycline for 3-13 days [9-26 g] presenting with jaundice and lethargy; peak AST 52-960 U/L; bilirubin 2.7-7.4 mg/dL, often with complex and critical course, pancreatitis and renal failure, acidosis; fatty liver on autopsy). 6021433
Damjanov I, Arnold R, Faour M. Tetracycline toxicity in a nonpregnant woman. JAMA 1968; 204: 934. (20 year old woman given iv tetracycline for 8 days after second of two gall bladder operations developed sudden onset of renal and hepatic failure [bilirubin 4.2 mg/dL, ALT 620 U/L], autopsy showed fatty liver and acute tubular necrosis). 5694615
Hansen CH, Pearson LH, Schenker S, Combes B. Impaired secretion of triglycerides by the liver; a cause of tetracycline-induced fatty liver. Proc Soc Exp Biol Med 1968; 128: 143-6. (Tetracycline induces fatty liver in rats at least in part due to inhibition of hepatic secretion of triglycerides). 5656682
Breitenbucher RB, Crowley LV. Hepatorenal toxicity of tetracycline. Minn Med 1970; 53: 949-55. (Seven patients with acute fatty liver from tetracycline, arising 5-11 days after starting iv tetracycline [6-19 g] with complex courses, but fatty liver on autopsy in all). 5470245
Kunin CM. Hepatorenal toxicity of tetracycline. Minn Med 1971; 5: 532-3. (Editorial in response to Breitenbucher questioning whether tetracycline was responsible for the clinical syndrome and attributing any injury to overdosage with tetracycline). 5564809
Robinson MJ, Rywlin AM. Tetracycline-associated fatty liver in the male. Report of an autopsied case. Am J Dig Dis 1970; 15: 857-62. (72 year old man given 10 days of iv tetracycline [30 g total] developed worsening liver injury followed by hepatic and renal failure and severe acidosis [bilirubin 6.8 mg/dL, AST 1550 KU/L, Alk P 15 KA U/L]; autopsy showed fatty liver, fatty vacuolization of renal tubular cells and pancreatitis). 5459744
Breen KJ, Perkins KW, Mistilis SP, Shearman R. Idiopathic acute fatty liver of pregnancy. Gut 1970; 11: 822-5. (23 year old woman who survived acute fatty liver of pregnancy; onset day after spontaneous labor and stillborn delivery [bilirubin 7.9 mg/dL, Alk P 70 King Armstrong U/L, AST 67 U/L, prothrombin index 50%], liver biopsy showed fatty liver, improved with dextrose administration). 5485832
Combes B, Whalley PJ, Adams RH. Tetracycline and the liver. Prog Liver Dis 1972; 4: 589-96. (Review of hepatotoxicity of tetracycline, including studies of pathogenesis). 4569011
Pride GL, Cleary RE, Hamburger RJ. Disseminated intravascular coagulation associated with tetracycline-induced hepatorenal failure during pregnancy. Am J Obstet Gynecol 1973; 115: 585-6. (23 year old pregnant woman developed jaundice [bilirubin 7.8 mg/dL, AST 346 U/L, Alk P 38 U/L] and oliguria 2 weeks after 2 im injections of tetracycline who delivered a normal child, but then had self-limiting disseminated intravascular coagulation and hemolytic anemia after delivery). 4685515
Whalley PJ, Combes B. Letter: Tetracycline toxicity. Am J Obstet Gynecol 1974; 118: 1149-51. (Letter in response to article by Pride et al. questioning the role of tetracycline because of dose and timing). 4817657
Lloyd-Still JD, Grand RJ, Vawter GF. Tetracycline hepatotoxicity in the differential diagnosis of postoperative jaundice. J Pediatr 1974; 84: 366-70. (3 children [ages 2, 3 and 10 years; all girls] with chronic urinary tract disease developed jaundice and liver failure after surgery and several days of iv tetracycline; 2 autopsies and one liver biopsy showed fatty liver). 4590715
Taneja OP, Grover NK, Thakur LC, Bhatia VN. Effects of blood levels of tetracycline and oxytetracycline on hepatic and renal functions in normal subjects. Chemotherapy 1974; 20: 201-11. (Mild increases in ALT and AST found in 20 healthy volunteers given oxytetracycline or tetracycline [1 g/day orally] for 5 days; no clinical symptoms or jaundice). 4413117
Schenker S. Tetracycline hepatotoxicity. A review. Mater Med Pol 1976; 8: 173-6.790035
Wenk RE, Gebhardt FC, Bhagavan BS, Lustgarten JA, McCarthy EF. Tetracycline-associated fatty liver of pregnancy, including possible pregnancy risk after chronic dermatologic use of tetracycline. J Reprod Med 1981; 26: 135-41. (Two cases of acute fatty liver over a 15 year period and 60,000 deliveries; one woman received tetracycline for 3 days, the second had no history of its use, but had tetracycline detected in bony tissue suggestive of chronic use). 7230149
Böcker R, Estler CJ, Müller S, Pfandzelter C, Spachmüller B. Comparative evaluation of the effects of tetracycline, rolitetracycline and doxycycline on some blood parameters related to liver function. Arzneimittelforschung 1982; 32: 237-41. (Minocycline caused a dose dependent rise in AST and increase in triglycerides, but no hepatic histological changes in mice; similar findings were previously reported with tetracycline). 7200783
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (Case control study using Medicaid billing results between 1980-87 found 107 cases of hospitalization for unexplained hepatitis, odds ratios for erythromycin 5.2; sulfonamides 11.4; tetracyclines 5.2; total of 5 cases exposed to tetracycline, doxycycline or minocycline). 8363168
Hunt CM, Washington K. Tetracycline-induced bile duct paucity and prolonged cholestasis. Gastroenterology 1994; 107: 1844-7. (Two cases of severe and prolonged cholestatic hepatitis and bile duct paucity after oral tetracyclines; 37 year old woman developed jaundice 2 days after 3 day course of doxycycline with prolonged cholestasis [peak bilirubin 30 mg/dL], but ultimate recovery; 63 year old woman developed jaundice 6 weeks after a 2 week course of tetracycline [bilirubin 11.8 mg/dL, ALT 245 U/L], with prolonged jaundice [peak bilirubin 29.5 mg/dL) and persistence of enzyme elevations for >3 years [Alk P 631 U/L, ALT 97 U/L]). 7958700
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; no tetracycline is mentioned as a cause). 1506809
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; triacetyloleandomycin accounted for 21 cases [2.1%] and minocycline for at least 4). 8816722
Tham SN, Kwok YK, Chan HL. Cross-reactivity in fixed drug eruptions to tetracyclines. Arch Dermatol 1996; 132: 1134-5. (Among 9 Chinese patients with a fixed drug eruption due to tetracycline, all had recurrence on doxycycline and 3 on minocycline; no mention of liver involvement). 8795565
Shapiro LE, Knowles SR, Shear NH. Comparative safety of tetracycline, minocycline, and doxycycline. Arch Dermatol 1997; 133: 1224-30. (Review of toxicity of tetracyclines from literature and a Canadian database; minocycline had the highest rates of adverse events, but all were relatively safe: no lupus-like syndrome associated with doxycycline or tetracycline). 9382560
Westermann GW, Böhm M, Bonsmann G, Rahn KH, Kisters K. Chronic intoxication by doxycycline use for more than 12 years. J Intern Med 1999; 246: 591-2. (38 year old man took large doses of doxycycline chronically and developed repeated bouts of mild jaundice [bilirubin 3.4-5.0 mg/dL, ALT 44-118 U/L, Alk P 466 U/L] and weakness, skin discoloration and heart block, resolving upon stopping). 10620103
Sturkenboom MC, Meier CR, Jick H, Stricker BH. Minocycline and lupuslike syndrome in acne patients. Arch Intern Med 1999; 159: 493-7. (Case control study in 27,688 acne patients in UK database, risk of lupus increased 8.5 fold in minocycline treated patients, not with other tetracyclines, typically long term therapy; liver involvement not mentioned; more common in women, absolute risk low). 10074958
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none of which were attributed to minocycline, doxycycline or tetracycline). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, one case was attributed to doxycycline, but no other tetracycline mentioned). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease; no tetracycline was listed among the top 20 agents implicated [at least 5 cases]). 16083708
Galan MV, Potts JA, Silverman AL, Gordon SC. The burden of acute nonfulminant drug-induced hepatitis in a United States tertiary referral center. J Clin Gastroenterol 2005; 39: 64-7. (Ten year experience of 96 patients with acute liver injury, 64 were due to viral hepatitis and 32 to drugs; minocycline accounted for 4 cases and ranked second in frequency [7 from amiodarone and 4 from amoxicillin/clavulanate]). 15599214
Chamberlain MC, Schwarzenberg SJ, Akin EU, Kurth MH. Minocycline-induced autoimmune hepatitis with subsequent cirrhosis. J Pediatr Gastroenterol Nutr 2006; 42: 232-5. (15 year old boy developed signs of cirrhosis after 1 year of minocycline therapy [bilirubin 2.5 mg/dL, ALT 67-83 U/L, Alk P normal, ANA 1:40, anti-DNA positive], treated with 6-mercaptopurine and prednisone with only partial response and found to have cirrhosis on follow up liver biopsy). 16456421
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; the list of most 21 most commonly implicated drugs did not include a tetracycline). 16054882
Margolis DJ, Hoffstad O, Bilker W. Association or lack of association between tetracycline class antibiotics used for acne vulgaris and lupus erythematosus. Br J Dermatol 2007; 157: 540-6. (Analysis of UK database on 97,694 subjects with acne, 25% received minocycline, 16% doxycycline and 45% other tetracyclines. Hazard ratio for lupus-like syndrome was 3.11 for minocycline; no increased risk or association with doxycycline or other tetracyclines). 17596147
Heaton PC, Fenwick SR, Brewer DE. Association between tetracycline or doxycycline and hepatotoxicity: a population based case-control study. J Clin Pharm Ther 2007; 32: 483-7. (Analysis of 2 years of Medicaid claims in California found 3377 cases of “hepatotoxicity”; 20 had received tetracycline <45 days before onset; only 4 controls had: adjusted odds ratio 3.7; not elevated for doxycycline; this despite safety record of oral tetracyclines and known hepatotoxicity of doxycycline). 17875115
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases and tetracycline was listed as a secondary possible cause for one). 18955056
Ramakrishna J, Johnson AR, Banner BF. Long-term minocycline use for acne in healthy adolescents can cause severe autoimmune hepatitis. J Clin Gastroenterol 2009; 43: 787-90. (3 cases of minocycline hepatotoxicity; 16 year olds with onset of jaundice 2, 13 and 24 months after starting minocycline for acne [bilirubin 19.6, 9.1 and 9.5 mg/dL, ALT 1282, 2306 and 2056 U/L, ANA 1:160-1:640], liver biopsies showing hepatitis and fibrosis; all treated with corticosteroids, 2 requiring prolonged therapy). 19262406
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 117 cases attributed to minocycline, but no other tetracycline listed in the top 40 causes). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were due to tetracyclines). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 to doxycycline but none to minocycline or other tetracyclines). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: Pathomechanisms and clinical. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics; mentions that hepatotoxicity from oral tetracycline is rare ~1.5 cases per million prescriptions, whereas minocycline has been associated with either an immediate reaction with eosinophilia, dermatitis and enzyme elevations or a delayed autoimmune hepatitis-like syndrome). 20107858
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a tetracycline). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 37 of which were attributed to an antibiotic, but none to a tetracycline). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 inpatients with hepatitis of unknown cause enrolled in a prospective case-cohort surveillance study between 2002 and 2011, one was attributed to doxycycline, but no other tetracycline was implicated). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline). 25754159
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period, identified 1435 cases of liver injury, the most being with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no details provided). 35364753
Drugs for acne. Med Lett Drugs Ther. 2024;66(1695):17-20.. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for acne mentions that oral tetracyclines are effective and well tolerated; no mention of ALT elevations or hepatotoxicity). 38294764
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline but none to eravacycline, omadacycline, sarecycline, or tigecycline). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Tetracycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(tetracycline/AE+OR+oxytetracycline/AE)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tetracycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tetracycline+OR+oxytetracycline)